# Meropenem

## OVERVIEW

### Introduction

Meropenem is a carbapenem antibiotic with broad spectrum of activity that is administered intravenously and used for severe bacterial infections due to sensitive agents. Meropenem is a common cause of mild transient aminotransferase elevations and can rarely result in clinically apparent, cholestatic liver injury.

### Background

Meropenem (mer" oh pen' em) is a broad spectrum, beta-lactam carbapenem antibiotic that acts by binding to the penicillin binding proteins and disrupting bacterial cell wall integrity and synthesis. Meropenem has a broad spectrum of activity against many aerobic and anaerobic gram-positive and gram-negative organisms, including Staphylococcus aureus, Streptococcus pyogenes, Streptococcus agalactiae, viridans group streptococci, Enterococcus faecalis, Pseudomonas aeruginosa, Escherichia coli, Proteus mirabilis, Bacteroides fragilis and Peptostreptococcus species. Meropenem was approved for use in the United States in 1996 and is currently indicated for the treatment of severe or complicated skin, tissue, intraabdominal and urogenital infections as well as sepsis due to susceptible organisms. Its use is generally reserved for severe infections in hospitalized patients. The recommended dosage is 0.5 to 1 gram given intravenously every 8 hours, with dose adjustment for renal impairment. Meropenem is available in vials of 500 mg or 1 gram of lyophilized powder for injection in generic forms and under the brand name Merrem. The most common side effects are diarrhea, nausea and vomiting, skin rash and pruritus.

### Hepatotoxicity

Serum aminotransferase elevations have been reported in 1% to 6% of recipients of intravenous meropenem when given for up to 14 days. These elevations are usually transient, mild and asymptomatic; and rarely require dose adjustment. Meropenem has also been linked to rare cases of cholestatic jaundice that usually arises after 1 to 3 weeks of therapy. Immunoallergic features may be present, but are rarely prominent. Autoantibodies are rare. Most cases are mild and self-limited, but at least one instance of vanishing bile duct syndrome related to meropenem therapy has been published (Case 1). Meropenem has not been reported to cause acute liver failure.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The cause of the mild, transient serum enzyme elevations during meropenem therapy is not known. The cholestatic hepatitis attributed to the carbapenems is probably immunoallergic and resembles the rare clinically apparent liver injury that has been linked to penicillins and cephalosporins.

### Outcome and Management

The liver injury due to the meropenem is usually mild and self-limited. Rarely, meropenem and other carbapenems can cause a clinically apparent and protracted cholestatic hepatitis that is usually self-limiting, but can lead to vanishing bile duct syndrome. In patients with vanishing bile duct syndrome, corticosteroids are often used, but have not been shown to be beneficial and are best avoided. Some patients may benefit from symptomatic therapy of the pruritus associated with cholestasis using antihistamines, ursodiol or cholestyramine. There is little information on possible cross sensitivity to liver injury among the different beta-lactam antibiotics, but patients with clinically apparent liver injury due to meropenem should probably avoid reexposure as well as other carbapenems.

References to the safety and potential hepatotoxicity of meropenem are given in the Overview section on Carbapenems.

Drug Class: Antiinfective Agents, Carbapenems

Other Drugs in the Subclass, Carbapenems: Doripenem, Ertapenem, Imipenem

## CASE REPORT

### Case 1. Cholestatic hepatitis and vanishing bile duct syndrome due to meropenem

(Modified from: Schumaker AL, Okulicz JF. Meropenem-induced vanishing bile duct syndrome. Pharmacotherapy 2010; 30: 335e-338e. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20812433)).

A 60 year old woman developed jaundice and pruritus 3 weeks after starting treatment with intravenous meropenem (1 g twice daily) for a brain abscess. Her medical history included type 2 diabetes, diabetic neprhopathy, hypertension and hyperlipidemia for which she was taking glipizide (5 mg daily), atorvastatin (40 mg daily), telmistartan (80 mg daily), and calcium acetate (667 mg thrice daily) long term. Two months before presentation with jaundice she developed a brain abscess thought to be a complication of otitis media. Cultures were negative and she was initially treated with ceftriaxone and metronidazole. Levetiracetam (250 mg twice daily) was started for control of seizures. Because of antibiotic induced leukopenia, her antibiotic regimen was changed to merepenem, which was continued for 3 weeks and discontinued promptly when she developed jaundice. At that time, examination revealed jaundice, but no fever, rash, lymphadenopathy, splenomegaly or hepatomegaly. Laboratory results showed a serum bilirubin of 11.2 mg/dL (direct 9.9 mg/dL), ALT 83 U/L, AST 238 U/L, alkaline phosphatase 1467 U/L and GGT 230 U/L. These values had been normal before she started meropenem (Table). The prothrombin time was 15.6 seconds and blood counts were normal. Serum creatinine was mildly elevated, but stable (2.4 mg/dL). Tests for hepatitis B and C were negative as were routine autoantibodies. Abdominal ultrasound followed by ERCP showed no abnormalities of the gallbladder or bile ducts. A liver biopsy showed marked cholestasis, mild inflammation and paucity of bile ducts in portal areas. She was treated with ursodiol and followed without other specific therapy. Her liver tests gradually improved, but she was still jaundiced 5 months later.

#### Key Points

Medication: | Meropenem
Pattern: | Cholestatic (R = 0.2)
Severity: | 4+ (prolonged Jaundice)
Latency: | 3 weeks
Recovery: | Incomplete at 5 months
Other medications: | Glipizide, atorvastatin, telmistartan, calcium, ceftriaxone, metronidazole, levetiracetam

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 25 | 100 | 0.5
0 | | 25 | 100 | 0.5 | Meropenem started
1 week | | 25 | 100 | 0.5
3 weeks | 0 | 83 | 1320 | 11.2 | Meropenem stopped
4 weeks | 1 week | 180 | 1467 | 16 | ERCP
5 weeks | 2 weeks | 130 | 1350 | 22 | Liver biopsy
6 weeks | 3 weeks | 110 | 1020 | 27
7 weeks | 4 weeks | 90 | 625 | 22
8 weeks | 5 weeks | 100 | 500 | 23
10 weeks | 7 weeks | 90 | 320 | 19
14 weeks | 11 weeks | 50 | 400 | 13
18 weeks | 15 weeks | 30 | 280 | 11
19 weeks | 16 weeks | 50 | 250 | 8
Normal Values | | <40 | <148 | <1.2

* Values estimated from Figure 1.

#### Comment

While the carbapenems can commonly cause asymptomatic serum enzyme elevations, clinically apparent liver injury from their use is quite rare. The few case reports in the literature suggest that the carbapenems cause a cholestatic hepatitis much like occurs with the penicillins and cephalosporins with a latency of 1 to 3 weeks and a mild, self-limiting course. The current report, however, demonstrates that severe cholestatic liver injury can result in bile duct damage and loss and, if sufficiently severe, can lead to prolonged cholestasis and jaundice and even end stage liver disease. While penicillin- and carbapenem induced cholestatic liver injury is believed to be immunologically mediated, patients do not always have immunoallergic features, such as rash, fever, facial edema and eosinophilia.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Meropenem – Generic, Merrem®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=meropenem)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Meropenem | 119478-56-7 | C17-H25-N3-O5-S.H2-O | Meropenem chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Meropenem: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=meropenem/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Meropenem: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=meropenem)